# Azithromycin

## OVERVIEW

### Introduction

Azithromycin is a semisynthetic macrolide antibiotic which is commonly used for a wide variety of mild-to-moderate bacterial infections. Azithromycin has been linked to rare instances of acute liver injury that can be severe and even fatal.

### Background

Azithromycin (ay zith" roe mye' sin) is a semisynthetic macrolide antibiotic used widely to treat mild-to-moderate bacterial infections caused by sensitive agents. Azithromycin, like other macrolide antibiotics such as erythromycin and clarithromycin, is bacteriostatic against many gram positive bacteria including many strains of streptococci, staphylococci, clostridia, corynebacteria, listeria, haemophilus sp., moxicella, and Neisseria meningitidis. Azithromycin is more active than erythromycin against several gram negative bacteria as well as Mycoplasma pneumonia, Helicobacter pylori, Toxoplasma gondii, cryptosporidia and several atypical mycobacteria. Macrolide antibiotics act by inhibiting protein synthesis of bacteria by binding to the 50S ribosomal element. Resistance occurs by several mechanisms. Azithromycin was approved for use in the United States in 1994 and currently it is the one of the most prescribed antibiotics in America. Typical indications are community acquired pneumonia, acute exacerbations of chronic bronchitis, sinusitis, pelvic inflammatory disease, urethritis and other infections caused by susceptible bacteria. Azithromycin is also used to treat disseminated mycobacterium avium complex infections. Azithromycin is available as tablets of 250 and 500 mg and as solutions and powders for suspension generically and under the name Zithromax. Azithromycin is typically given in once daily doses for 5 to 7 days. Chronic use of azithromycin is used to treat atypical mycobacterial infections and as prophylaxis against common bacterial infections in highly susceptible persons (with cystic fibrosis, chronic granulomatous disease, or bronchiectasis). Parenteral azithromycin is typically given in doses of 500 mg iv daily for the first few days of therapy in moderate-to-severe infections. Azithromycin is generally well tolerated, but side effects can include nausea, abdominal pain, diarrhea, dyspepsia, headache, dizziness, angioedema and rash. Severe adverse reactions include infantile pyloric stenosis, Clostridia difficile diarrhea, QTc prolongation, hepatotoxicity and severe hypersensitivity reactions including Stevens Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

Like other macrolide antibiotics, azithromycin has been linked to a low rate of acute, transient and asymptomatic elevation in serum aminotransferases which occurs in 1% to 2% of patients treated for short periods, and a somewhat higher proportion of patients given azithromycin long term.

Azithromycin can also rarely cause clinically apparent liver injury. Because azithromycin has become so commonly used, it has also become one of the more common causes of drug induced liver injury. In large case series of drug-induced liver injury, azithromycin is usually listed as one of the top ten causes. The estimates of the incidence of clinically apparent liver injury with azithromycin therapy ranges widely from 1:2500 to 1:65,000, perhaps because of differences in risk with oral (outpatient) versus parenteral (inpatient) therapy. The typical liver injury caused by azithromycin resembles that described with other macrolides and is a self-limited, cholestatic hepatitis, arising within a few weeks after starting treatment, often days or even a few weeks after azithromycin is stopped (Case 1). The latency to onset can be quite short, within 3 days of starting azithromycin, but the usual time to clinical onset is 1 to 3 weeks. Typical symptoms are fatigue, jaundice, abdominal pain and pruritus. Fever and eosinophilia may also be present, but immunoallergic features are usually not prominent. This form of liver injury from azithromycin is usually benign, but in some instances is associated with prolonged jaundice and persistence of liver test abnormalities for 6 months or more. Liver histology in these cases generally demonstrates bile duct loss, which if severe, can result in vanishing bile duct syndrome and chronic cholestatic liver failure, ultimately requiring liver transplantation. Milder instances of bile duct loss and prolonged cholestatic hepatitis ultimately resolve but may be marked by persistent serum alkaline phosphatase elevations of uncertain clinical significance.

Azithromycin can also cause hepatocellular injury with symptoms of fatigue, abdominal pain, and jaundice. In these cases, the latency is typically short and may be 1 to 3 days only (Case 2). Serum aminotransferase levels are markedly elevated and alkaline phosphatase values are usually less than twice the upper limit of normal, although they may rise to higher levels with time. The hepatocellular forms of liver injury from azithromycin can be severe and lead to acute liver failure and death or need for emergency liver transplantation. However, in most cases, recovery occurs within 4 to 8 weeks.

Azithromycin has also been associated with severe cutaneous reactions such as erythema multiforme, drug reaction with eosinophilia and systemic signs (DRESS) syndrome, Stevens Johnson syndrome (SJS) and toxic epidermal necrosis (TEN). These severe cutaneous reactions are often associated with some degree of liver injury and may be accompanied by clinically apparent injury with jaundice, usually with a cholestatic pattern. However, the severe cutaneous reactions usually overshadow the liver injury.

In cell culture, azithromycin exhibits some degree of antiviral activity and was shown to inhibit the Severe Acute Respiratory Syndrome, coronavirus type 2 (SARS-CoV-2), the cause of the pandemic of severe COVID-19 pneumonia that arose in 2019 and led to more than 3 million deaths worldwide. In view of the antiviral activity as well as antiinflammatory actions of azithromycin, it was repurposed as a potential therapy of COVID-19. Despite early promising reports, subsequent randomized controlled trials found that it had no benefit in either prevention of infection or amelioration of the course of COVID-19 illness. An emergency use authorization granted to azithromycin as therapy of COVID-19 in early 2020 was later withdrawn.

Likelihood score: A (well known but rare cause of clinically apparent liver injury).

### Histopathology

Azithromycin hepatotoxicity is typically associated histologically with a cholestatic hepatitis similar to what is described with erythromycin induced liver injury. Scattered bile casts are found in canaliculi with modest parenchymal inflammation and necrosis. Portal tracts often have more pronounced inflammation characterized by mononuclear cells and eosinophils. The cholestasis can be profound and prolonged, and azithromycin is a well known cause of vanishing bile duct syndrome. Less common is hepatocellular injury, a pattern seen most commonly with reexposure, with a short latency to onset and biopsy taken early in the course of injury.

CHOLESTATIC HEPATITIS with Bile Plugs and Scant Parenchymal Inflammation

| Cholestasis with duct paucity. In this case, more than 90% of the portal areas lacked a bile duct. In this portal area, there is mild inflammation with rare eosinophils. The artery (A) and vein (V) can be seen, but there is no duct and no ductular reaction.
| Small bile plugs can be seen in dilated canaliculi in zone 3 (arrows). There was very little parenchymal inflammation in this case and the hepatocytes show cytoplasmic glycogenosis. The central vein (V) is the bottom left corner.

VANISHING BILE DUCT SYNDROME

| Bile duct injury was seen in most of the portal areas, although there was very little inflammation. The bile ducts (arrows) show different kinds of injury. In the portal area on the left, the duct epithelium is attenuated, and there is a suggestion of periductal fibrosis. In the portal area on the right, the bile duct epithelium shows reactive changes, with enlarged, irregularly spaced nuclei that have open chromatin.
| There was mild predominantly lobular inflammation with scattered small foci of lymphocytes and macrophages (arrows). Rare apoptotic hepatocytes were also present (not shown). The central vein is indicated (V).
| This patient had prolonged cholestasis and a biopsy was performed almost a year after the onset of the injury. There was almost no inflammation in the portal areas or parenchyma and the bile ducts were intact. However, bile plugs could still be found with dilated canaliculi in zone 3 (arrows).

### Mechanism of Liver Injury

The cause of the idiosyncratic liver injury due to azithromycin is unknown, but the rapidity of onset suggests hypersensitivity as a cause.

### Outcome and Management

The minor serum aminotransferase elevations that appear during therapy with azithromycin are usually benign, asymptomatic and resolve rapidly whether or not azithromycin is stopped. The acute hepatic injury with jaundice, however, can be prolonged and troublesome and lead to loss of intrahepatic bile ducts and vanishing bile duct syndrome. The injury and jaundice may arise after azithromycin is stopped, but appearance of jaundice in someone on azithromycin should lead to its prompt discontinuation. Rare instances of acute liver failure and fatality from azithromycin induced liver disease have been reported. Persons with preexisting, underlying chronic liver disease may be more susceptible to severe outcomes. There is likely to be cross reactivity in hepatic injury with other macrolide antibiotics, but this has not been well documented.

Drug Class: Antiinfective Agents, Macrolide Antibiotics

## CASE REPORTS

### Case 1. Cholestatic hepatitis after azithromycin.(1)

A 69 year old man with community acquired pneumonia was treated with azithromycin (500 mg daily) for 3 days and developed dark urine and jaundice 3 days later. Laboratory tests showed marked elevations in alkaline phosphatase and bilirubin with modest increases in ALT and AST levels (Table). He tested negative for markers of hepatitis A, B and C infection, and liver ultrasound was normal. He was given ceftriaxone for his unresolved bronchopneumonia and recovered within the next few weeks.

#### Key Points

Medication: | Azithromycin (500 mg daily for 3 days)
Pattern: | Cholestatic (R=0.4)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 week
Recovery: | Complete within one month
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Dark urine and jaundice 3 days after stopping azithromycin
1 week | 4 days | 49 | 890 | 9.1 | GGT 131
2 weeks | 11 days | 90 | 1200 | 15.2
3 weeks | 18 days | 156 | 450 | 6.0
4 weeks | 25 days | 30 | 210 | 1.2 | GGT 45
Normal Values | | <40 | <280 | <1.2

#### Comment

This was an early case report of azithromycin hepatotoxicity and clearly demonstrated its typical clinical pattern of abrupt onset of illness within a week of starting the medication—and actually a few days after stopping it. The cholestatic pattern of liver enzymes and jaundice are typical (but not invariable) of azithromycin hepatotoxicity. There was no mention of signs of hypersensitivity such as fever, rash, arthralgias or eosinophilia, although the concurrent pneumonia may have confounded the clinical picture. Recovery was reasonably rapid, but the benign outcome may have been because azithromycin was given for 3 days only. This patient should be advised against future exposure to azithromycin, but there is little information about his risks of liver injury with other macrolide antibiotics (such as erythromycin or clarithromycin).

### Case 2. Hepatocellular liver injury due to azithromycin.(2)

A 69 year old woman developed weakness, anorexia, nausea, diarrhea, pruritus and jaundice 4 days after starting oral azithromycin (1000 mg initially, then 500 mg daily) for suspected acute bronchitis. She had no history of liver disease, did not drink alcohol and had no risk factors for viral hepatitis. Her past medical history included hypertension, dyslipidemia, a 50 pack year history of cigarette smoking, chronic obstructive pulmonary disease, hypothyroidism and depression for which she was taking lisinopril, simvastatin, aspirin, loratadine, albuterol by inhaler, levothyroxine and fluoxetine. She was also increasingly symptomatic from her acute pulmonary infection. Physical examination revealed jaundice but no fever, rash or organomegaly. She was dyspneic and had basilar inspiratory crackles and signs of consolidation. Laboratory tests showed bilirubin of 2.0 (direct 0.9) mg/dL, ALT 1065 U/L, AST 2001 U/L, Alk P 125 U/L and INR of 2.3 (Table). Tests for acute hepatitis A, B and C (including HCV RNA) were negative. ANA was negative, but smooth muscle antibody was reactive. A chest CT showed bibasilar pulmonary consolidations. She was admitted to the hospital, azithromycin was held and levofloxacin started. The following day she had a respiratory arrest, but was successfully resustained and placed on mechanical ventilation. Ultrasound of the abdomen showed no evidence of biliary obstruction although there was biliary sludge and gallbladder wall thickening. Over the first week of admission her serum enzymes remained high and serum bilirubin climbed to 18.5 mg/dL. However, her pulmonary status improved, she was successfully extubated and was eventually discharged on her previous medications without antibiotics and with improving serum enzymes. When seen in the outpatient clinic 2 and 5 months later, her liver tests were normal.

#### Key Points

Medication: | Azithromycin (500-1000 mg daily orally for 4 days)
Pattern: | Hepatocellular (R=20)
Severity: | 4+ (jaundice, hospitalization, prolonged INR)
Latency: | 4 days
Recovery: | Complete within two months
Other medications: | Chronically: lisinopril, simvastatin, aspirin, albuterol, loratadine, levothyroxine, fluoxetine

#### Laboratory Values

Time After Starting | Time After Starting | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Fatigue, weakness, nausea and jaundice 4 days after starting azithromycin
4 days | 0 | 1065 | 125 | 2.0 | Admission, INR 2.3
5 days | 1 days | 4068 | 140 | 2.9 | Respiratory arrest
7 days | 3 days | 1101 | 134 | 11.6
14 days | 10 days | 198 | 89 | 15.4
| 2 months | 35 | 89 | 1.6 | Outpatient
| 5 months | 19 | 73 | 0.4
Normal Values | | <54 | <126 | <1.2

#### Comment

The rapidity of onset of injury after starting azithromycin suggests previous exposure either to azithromycin specifically or to another macrolide. The initial injury was distinctly hepatocellular, with ALT levels 20 fold elevated and alkaline phosphatase at the upper limit of the normal range. The clinical course was complicated by a fairly severe pneumonitis in the setting of chronic obstructive pulmonary disease that led to a respiratory arrest, which may have accounted for the second rise in ALT levels and worsening of jaundice for 7 to 10 days after stopping the implicated antibiotic. Several of the other medications she was taking have a potential to cause acute liver injury, but all were restarted without recurrence. Thus, while atypical in some regards, the timing and course of the liver injury make azithromycin the most likely cause.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Azithromycin — Generic, Zithromax®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=azithromycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Azithromycin Dihydrate | 117772-70-0 | C38-H72-N2-O12.2H2O

Azithromycin is a macrolide antibiotic and semisynthetic derivative of erythromycin with a methyl-substituted nitrogen atom in the large lactone ring. It is orally bioavailable, has a prolonged half-life (allowing for once daily administration), and exhibits excellent tissue penetration and distribution.

## CITED REFERENCES

1 Longo G, Valenti C, Gandini G, Ferrara L, Bertesi M, Emilia G. Azithromycin-induced intrahepatic cholestasis. Am J Med 1997; 102: 217-8.9217574
2 Lockwood AM, Cole S, Rabinovich M. Azithromycin-induced liver injury. Am J Health Syst Pharm 2010; 67: 810-4.20479103

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2025

Zimmerman HJ. Erythromycins. In, Zimmerman HJ. Hepatotoxicity: The adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Wilkins, 1999, pp. 594-5. (Expert review of erythromycin and liver injury published in 1999; mentions clarithromycin, but not azithromycin).
Moseley RH. Macrolide antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 466-7. (Expert review of macrolide antibiotic induced liver injury; mentions that cholestatic injury has been reported with azithromycin).
MacDougall C. Macrolides and ketolides. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan, R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1053-1056. (Textbook of pharmacology and therapeutics).
Girard AE, Girard D, English AR, Gootz TD, Cimochowski CR, Faiella JA, et al. Pharmacokinetic and in vivo studies with azithromycin (CP-62,993), a new macrolide with an extended half-life and excellent tissue distribution. Antimicrob Agents Chemother 1987; 31: 1948-54. (Preclinical pharmacology of azithromycin, its advantages over erythromycin are that it has a longer half-life and excellent tissue distribution). 2830841
Vial T, Biour M, Descotes J, Trepo C. Antibiotic-associated hepatitis: update from 1990. Ann Pharmacother 1997; 31: 204-20. (Extensive review including discussion of three macrolides [erythromycin, clarithromycin and azithromycin], ALT elevations occur in 0.4-1.2% of treated patients but similar rates found in placebo controls; rare instances of cholestatic hepatitis have been reported with all three macrolide antibiotics). 9034423
Hopkins S. Clinical toleration and safety of azithromycin. Am J Med 1991; 91(3A): 40S-45S. (Review of side effects of azithromycin in 3995 patients treated for 1-5 days: side effects occurred in 12%, most commonly gastrointestinal symptoms; transient increases in ALT in 1.7% and AST in 1.5%, but similar or higher rates [2.5% and 1.0%] with comparative drugs, 2 patients withdrawn because of ALT elevations, but no mention of hepatitis or jaundice). 1656742
Longo G, Valenti C, Gandini G, Ferrara L, Bertesi M, Emilia G. Azithromycin-induced intrahepatic cholestasis. Am J Med 1997; 102: 217-8. (69 year old man developed jaundice 3 days after a 3 day course of azithromycin [peak bilirubin 16.2 mg/dL, ALT 156 U/L, Alk P 1200 U/L], resolving within 2 weeks of stopping: Case 1). 9217574
Macaigne G, Mokbel M, Marty O, De La Lande P, Mallet L. [Acute pseudoangiocholitic hepatitis probably induced by azithromycin] Gastroenterol Clin Biol 2000; 24: 969-70. French. (55 year old woman developed fever, jaundice and right upper quadrant pain 18 days after starting a 5 day course of azithromycin [bilirubin of 8.9 mg/dL ALT 2.8 times and Alk P 3.5 times ULN], resolving within 3 weeks of stopping except for residual mild Alk P elevations). 11084438
Cascaval RI, Lancaster DJ. Hypersensitivity syndrome associated with azithromycin. Am J Med 2001; 110: 330-1. (79 year old man developed rash, fever and eosinophilia 10 days after starting a 5 day course of azithromycin, with renal failure and obtundation [bilirubin not given, ALT 210 U/L, Alk P 1512 U/L], resolving rapidly but scant data given). 11247598
Chandrupatla S, Demetris AJ, Rabinovitz M. Azithromycin-induced intrahepatic cholestasis. Dig Dis Sci 2002; 47: 2186-8. (72 year old man developed jaundice 12 days after starting a 5 day course of azithromycin [bilirubin 3.3 mg/dL, ALT 156 U/L, Alk P 349 U/L], resolving within next month). 12395890
Equi A, Balfour-Lynn IM, Bush A, Rosenthal M. Long term azithromycin in children with cystic fibrosis: a randomised, placebo-controlled crossover trial. Lancet 2002; 360(9338): 978-84. (Controlled, crossover trial of azithromycin vs placebo for 6 months in 41 children with cystic fibrosis; one child developed ALT elevations >3 times ULN, improving upon stopping). 12383667
Suriawinata A, Min AD. A 33-year-old woman with jaundice after azithromycin use. Semin Liver Dis 2002; 22: 207-10. (33 year old woman developed jaundice 4 days after completing a 5 day course of azithromycin and 1 day after starting erythromycin [bilirubin 11.3 mg/dL, ALT 583 U/L, Alk P 228 U/L], with severe pruritus, resolving within 2 months of onset). 12016551
Sopena N, Martínez-Vázquez C, Rodríguez-Suárez JR, Segura F, Valencia A, Sabrià M. Comparative study of the efficacy and tolerance of azithromycin versus clarithromycin in the treatment of community-acquired pneumonia in adults. J Chemother 2004; 16: 102-3. (Comparison of 3 days of azithromycin vs 10-14 days of clarithromycin in 70 adult patients with pneumonia showing similar efficacy [>90%] and frequency of side effects [26.5% vs 25%], with no mention of hepatic injury). 15078008
Baciewicz AM, Al-Nimr A, Whelan P. Azithromycin-induced hepatoxicity. Am J Med 2005; 118: 1438-9. (75 year old woman developed jaundice 2 days after completing a 3 day course of azithromycin [peak bilirubin 30.7 mg/dL, ALT 909 U/L, Alk P 357 U/L], resolving within ensuing 8 weeks). 16378809
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 5 cases were attributed to telithromycin and 3 to azithromycin as single agents, but none to erythromycin or clarithromycin). 18955056
Juricic D, Hrstic I, Radic D, Skegro M, Coric M, Vucelic B, Francetic I. Vanishing bile duct syndrome associated with azithromycin in a 62-year-old man. Basic Clin Pharmacol Toxicol 2010; 106(1): 62-5. Erratum in Basic Clin Pharmacol Toxicol 2010; 107(2): 700. (62 year old man developed rash and fever [Stevens Johnson syndrome] after 3 days of azithromycin therapy which resolved on prednisone, but 2 weeks later jaundice and pruritus appeared [bilirubin 15.0 mg/dL, ALT 1545 U/L, Alk P 545 U/L]; serum enzymes then decreased, but bilirubin levels remained high; liver biopsy showed duct loss and patient developed intractable pruritus and jaundice and underwent liver transplantation 7 months after initial presentation). 19906050
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review; the macrolide antibiotics may cause cholestatic hepatitis at an estimated rate of 3.6 per 100,000). 20107858
Lockwood AM, Cole S, Rabinovich M. Azithromycin-induced liver injury. Am J Health Syst Pharm 2010; 67: 810-4. (69 year old woman developed jaundice and pruritus 4 days after starting azithromycin [bilirubin 2.0 rising to 18.5 mg/dL, ALT 1065 U/L, Alk P 125 U/L], resolving within 2 months of stopping: Case 2). 20479103
Caramaschi P, Mahamid H, Bambara LM, Biasi D. Liver impairment after concomitant administration of bosentan and clarithromycin in systemic sclerosis. Joint Bone Spine 2010; 77: 81-2. (Two cases, 47 and 69 year old women with systemic sclerosis were treated with bosentan without difficulty, but developed ALT elevations [peak 503 and 94 U/L, Alk P 263 and 293 U/L] without jaundice within 5-7 days of starting clarithromycin, which resolved with stopping both or either, attributed to drug-drug interactions). 20022782
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 31 were due to antibiotics including one due to clarithromycin, but none were attributed solely to azithromycin or erythromycin). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 63 cases attributed to azithromycin, 60 to erythromycin and 35 to clarithromycin). 21039766
Das BK. Azithromycin induced hepatocellular toxicity and hepatic encephalopathy in asymptomatic dilated cardiomyopathy. Indian J Pharmacol 2011; 43: 736-7. (76 year old man developed nausea and abdominal pain 3 days after starting azithromycin and ranitidine followed by jaundice, itching and confusion [bilirubin 7 mg/dL, ALT 1640 U/L, Alk P 1894 U/L, INR 2.2], resolving rapidly on stopping). 22144789
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 6 [1.1%] attributed to macrolide antibiotics). 22379337
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to azithromycin or other macrolide antibiotics). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to clarithromycin [acute liver failure], but none were attributed to azithromycin). 24552865
Ferrajolo C, Coloma PM, Verhamme KM, Schuemie MJ, de Bie S, Gini R, Herings R, et al.; EU-ADR consortium. Signal detection of potentially drug-induced acute liver injury in children using a multi-country healthcare database network. Drug Saf 2014; 37: 99-108. (Analyses of large spontaneous reporting databases from 3 European countries between 1995 and 2010 identified 125 drugs with at least one exposed case of unexplained acute liver injury in children, 20 of which had a statistically significant association, including clarithromycin [5 cases] and erythromycin [4 cases], but not azithromycin). 24446276
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a nested case control analysis of a health care network database of persons between 2001 and 2009, 8 selected antibiotics were assessed for association with risk of hospitalization for liver injury, adjusted relative risks being significantly elevated for levofloxacin [3.2], moxifloxacin [2.3], doxycycline [2.5], amoxicillin/clavulanate [2.5] and amoxicillin [2.3], but not for clarithromycin [1.8], telithromycin [1.7] or cefuroxime [0.9]). 24865821
Moy BT, Dojki FK, Scholes JV, Hoffman MG. Azithromycin-induced cholestatic hepatitis. Conn Med 2015; 79: 213-5. (65 year old man developed jaundice 2 weeks after starting a 5 day course of azithromycin [bilirubin 17.2 mg/dL, ALT 63 U/L, Alk P 613 U/L, INR 1.1], resolving clinically over the next several months, but with persistent Alk P elevations). 26259299
Martinez MA, Vuppalanchi R, Fontana RJ, Stolz A, Kleiner DE, Hayashi PH, Gu J, et al. Clinical and histologic features of azithromycin-induced liver injury. Clin Gastroenterol Hepatol 2015; 13: 369-376.e3. (Among 18 patients with azithromycin induced liver injury enrolled in a US database between 2004 and 2013, the average age was 37 [range 2 to 76] years, 72% were women, latency averaged 17 days, 89% had jaundice, 44% had a cholestatic or mixed and 56% hepatocellular pattern, 1 case was fatal and 1 underwent liver transplant, 29% had chronic liver test abnormalities, and 2 had severe cutaneous reactions). 25111234
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 29 due to macrolides of which 18 were linked to azithromycin [2%], making it the 7th most frequently implicated medication). 25754159
Koffas A, Murray-Lyon IM, Williams R. Azithromycin-induced cholestatic hepatitis. Oxf Med Case Reports 2017; 2017: omx027. (69 year old man developed fever and jaundice 2 weeks after a 3 day course of azithromycin [bilirubin 12.3 rising to 21.1 mg/dL, ALT 415 U/L, Alk P 145 rising to 768 U/L, INR 0.9], resolving within 2 months with prednisone therapy that was later withdrawn without relapse). 28580159
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf 2017; 40: 305-15. (In a health care database of 429,772 children in Italy and the Netherlands followed between 2008 and 2010, 938 cases of liver injury of uncertain cause were identified, the rate being higher in those with current use of antibiotics [12% vs 3.6%] for an adjusted odds rate ratio [aOR] of 3.2; specific antibiotics most commonly implicated were fluoroquinolones [19.0], cephalosporins [4.5], macrolides [3.5] and penicillins [2.6], and a specific aOR for azithromycin of 2.4). 28025733
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al.; U.S. Drug Induced Liver Injury Network Investigators. Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology 2017; 65: 1267-77. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 2 cases attributed to azithromycin both of whom developed evidence for chronic liver injury suggestive of vanishing bile duct syndrome). 27981596
Han B, Sheng Y, Wang L, Feng H, Hou X, Li Y. Intrahepatic cholestasis of pregnancy or azithromycin-induced intrahepatic cholestasis: A case report. Medicine (Baltimore) 2017; 96: e9346. (30 year old woman in 38th week of pregnancy developed pruritus 4 days after starting azithromycin [bilirubin not given, ALT 37 Alk P 240 U/L, bile acids 10 fold elevated] which was thought to be either intrahepatic cholestasis of pregnancy or azithromycin liver injury, with full resolution within 10 days of stopping drug and Caesarian section). 29384912
Ellison CA, Blackwell SB. Acute Hepatocellular Injury Associated With Azithromycin. J Pharm Pract 2021; 34(3): 493-6. (83 year old man with pneumonia treated with multiple antibiotics including azithromycin developed elevations in ALT [1002 U/L], AST [1895 U/L] and LDH [2051 U/L], with minimal increase in Alk P [peak=125 U/L] and bilirubin [peak=2.2 mg/dL], one day later which continued to rise after stopping other drugs until azithromycin was stopped on day 5 with prompt improvement). 31928122
Ramírez E, Urroz M, Rodríguez A, González-Muñoz M, Martín-Vega A, Villán Y, Seco E, et al. Incidence of suspected serious adverse drug reactions in corona virus disease-19 patients detected by a pharmacovigilance program by laboratory signals in a tertiary hospital in Spain: cautionary data. Front Pharmacol 2020; 11: 602841. (Among 2682 hospitalized patients with COVID-19, routine laboratory data suggested that severe adverse events were 3-fold more common than among patients without COVID-19 [from 2020 and 2019], higher rates being for hepatic, renal and muscle signals in COVID-19 patients and seen during therapy with many of the drugs used including azithromycin). 33343374
Gyselinck I, Janssens W, Verhamme P, os R. Rationale for azithromycin in COVID-19: an overview of existing evidence. BMJ Open Respir Res 2021; 8: e000806. (Review of the rationale for use of azithromycin in COVID-19 infection including its effects on receptor binding, endosomal acidification, alternations in metabolic and inflammatory pathways, effects on cytokine production and function and on T cells, B cells and neutrophils). 33441373
Dauner DG, Dauner KN. Summary of adverse drug events for hydroxychloroquine, azithromycin, and chloroquine during the COVID-19 pandemic. J Am Pharm Assoc (2003) 2021: S1544-3191(21)00008-X. (Review of the FDA adverse drug reports for January to July 2020 for azithromycin, chloroquine and hydrochloroquine, including rise in reports from 592 before to 2492 after their emergency use authorization for COVID-19 infection, mostly for hydroxychloroquine [596] and azithromycin [184], the second most frequent event being “hepatitis”).
Melo JRR, Duarte EC, Moraes MV, Fleck K, Silva ASDNE, Arrais PSD. Adverse drug reactions in patients with COVID-19 in Brazil: analysis of spontaneous notifications of the Brazilian pharmacovigilance system. Cad Saude Publica 2021; 37: e00245820. (In Brazil between March and August 2020, a total of 631 adverse event reports in 402 patients with COVID-19 were received between March and August 2020, of which 56 cases [9%] were hepatic including 28 attributed to hydroxychloroquine [2 fatal], 4 azithromycin [1 fatal], and 2 chloroquine [2 fatal]). 33503163
RECOVERY Collaborative Group. Azithromycin in patients admitted to hospital with COVID-19 (RECOVERY): a randomised, controlled, open-label, platform trial. Lancet 2021; 397(10274): 605-12. (Among 2582 hospitalized patients with COVID-19 pneumonia randomized to receive azithromycin [500 mg daily for 10 days] vs 5181 given usual care, the mortality rate in the two groups was identical [22%] and duration of hospitalization similar [10 vs 11 days]; only one serious adverse event was reported due to azithromycin: a self-limited case of pseudomembranous colitis). 33545096
PRINCIPLE Trial Collaborative Group. Azithromycin for community treatment of suspected COVID-19 in people at increased risk of an adverse clinical course in the UK (PRINCIPLE): a randomised, controlled, open-label, adaptive platform trial. Lancet 2021; 397(10279): 1063-74. (In an adaptive UK based study with a randomized trial of azithromycin [500 mg daily for 3 days] or usual care in patients with suspected COVID-19 who were above the age of 65 years [or above the age of 50 with comorbidities], the rates of recovery by 28 days were similar [80% vs 77%] and there were no deaths and few adverse events that could be related to drug). 33676597
Akkerman-Nijland AM, Möhlmann JE, Akkerman OW, Vd Vaart H, Majoor CJ, Rottier BL, Burgerhof JGM, et al. The long-term safety of chronic azithromycin use in adult patients with cystic fibrosis, evaluating biomarkers for renal function, hepatic function and electrical properties of the heart. Expert Opin Drug Saf. 2021;20:959-963.. (Among 72 patients with cystic fibrosis treated chronically with azithromycin for prophylaxis of pulmonary infection for a cumulative period of 365 years there was no differences in changes in serum aminotransferase levels compared to 19 controls and no instance of azithromycin-induced liver injury). 34030570
Wong KM, Hosseinnejad K, Palaparty P, Ravakhah K. Azithromycin-induced liver injury in Legionnaires' disease. Cureus. 2021;13:e17856.. (66 year old man developed pneumonitis attributed to Legionnaires disease with abnormal liver tests on presentation [bilirubin 2.1 mg/dL, ALT 236 U/L, ASST 295 U/L, Alk P 96 U/L], which worsened within two days of starting intravenous daily azithromycin [250 mg] and ceftriaxone [1 g] with ALT 1035 U/L, AST 1135 U/L, Alk P 192ULN, which decreased after the two antibiotics were stopped). 34660061
Delgado A, Stewart S, Urroz M, Rodríguez A, Borobia AM, Akatbach-Bousaid I, González-Muñoz M, et al. Characterization of drug-induced liver injury in patients with COVID-19 detected by a proactive pharmacovigilance program from laboratory signals. J Clin Med. 2021;10:4432.. (A pharmacovigilance program in a Spanish referral medical center during March to December 2020 identified evidence of drug-induced liver injury [ALT greater than 5 times ULN] in 351 of 36,905 inpatients, 56 attributed to azithromycin, rates being higher after COVID-19 infection most cases being hepatocellular [57%], mild [88%,] and self-limited [88%]). 34640458
Liang R, Ramdass A. Azithromycin-induced liver injury in an asthma exacerbation patient with autoimmune features. Cureus. 2022;14:e25447.. (73 year old woman with asthma was treated for 5 days with oral azithromycin and developed fatigue, pruritus, followed by jaundice shortly thereafter [bilirubin 11.9 mg/dL, ALT 502 U/L, AST 945 U/L, Alk P 636 U/L, INR 1.4], with slow recovery on stopping). 35774698
Gu S, Rajendiran G, Forest K, Tran TC, Denny JC, Larson EA, Wilke RA. Drug-induced liver injury with commonly used antibiotics in the All of Us Research Program. Clin Pharmacol Ther. 2023;114:404-412.. (Among 318,598 participants in an electronic health record research cohort enrolled between 1984 and 2022, more than 30% had been exposed to at least 1 of 5 commonly used antibiotics including 55,053 who had received azithromycin, of whom 24 developed liver injury for an estimated incidence of 1 per 2,300 persons treated; furthermore, the mean age and BMI were similar in persons with and without liver injury after receiving azithromycin). 37150941
Mongare N, Orare K, Busaidy S, Sokwala A, Opio C. Plasma exchange for refractory pruritus due to drug-induced chronic cholestasis following azithromycin misuse in COVID-19 infection. Cureus. 2024;16:e60884.. (Two patients, a 60 year old man and 48 year old woman who developed severe and persistent pruritus shortly after taking an over-the-counter azithromycin for COVID-19 infections [bilirubin 23.8 and 2.6 mg/dL, ALT 126 and 179 U/L, Alk P 220 and 179 U/L, R 1.7 and 1.9], both of whom improved symptomatically after 2 sessions of total plasma exchange; only short term follow up provided). 38910696
Conlon C, Li YJ, Ahmad J, Barnhart H, Fontana RJ, Ghabril M, Hayashi PH, et al.; Drug‐Induced Liver Injury Network (DILIN). Clinical characteristics and HLA associations of azithromycin-induced liver injury. Aliment Pharmacol Ther. 2024;60:787-795.. (Among 1635 cases of drug-induced liver injury enrolled in a US prospective study between 2004 and 2022, 30 cases were attributed to azithromycin, with a median age of 46 years, 60% female, median latency of 12.5 days, serum enzymes hepatocellular [60%) or cholestatic [27%], 33% scored as severe or fatal [3 cases], associated with HLA-A*03:01 in Caucasians). 38988034
Barritt AS 4th, Hayashi PH, Stolz AA, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network (DILIN). Refinement of Hy Law Using the Drug-Induced Liver Injury Network Database. Am J Gastroenterol. 2024; 120:1307-131.. (Among 1718 cases of drug induced liver injury enrolled in a U.S. prospective study between 2004 and 2021, azithromycin ranked 7^th^ as a cause of jaundice accounting for 26 cases which were mostly hepatocellular, 4 of which were fatal [15%] as would be expected according to Hy’s Law). 39422332
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, at a rate of 1 per 2,500 patients exposed to azithromycin). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 26 cases of due to diclofenac which was estimated as an incidence of 1 per 65,000 persons treated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 109 were attributed to antibacterials, the most frequently implicated being amoxicillin/clavulanate [n=58] drugs for tuberculosis [n=27], and nitrofurantoin [n=20], no mention of azithromycin). 38992407
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1.. (Analysis of a health database of 16 Indiana University Health hospitals, identified 54 cases of drug-induced liver injury caused by 8 commonly implicated agents, the most frequent being azithromycin with 15 cases and an estimated incidence of 1 per 3540 treated, hospitalized patients). 39447947
Björnsson RA, Sigurdsson SS, Arnarson DT, Logason E, Björnsson ES. The frequency of drug-induced liver injury due to antibiotics among hospitalised patients. Drug Saf. 2025;48:795-804.. (Among 2292 hospitalized patients who were treated with 14 different antibiotics while in the Landspitali University Hospital of Iceland between 2012 and 2023, 52 developed evidence of drug-induced liver disease including 23 of 30,513 who received amoxicillin-clavulanate [1:1,327], 7 of 44,538 after cefazolin [1:6,363], 4 of 24,095 after cloxacillin [1:6,024], and 3 of 3288 after trimethoprim/sulfamethoxazole [1:1096]; but no cases were attributed to azithromycin). 40072769
Wells DA, Eick J. Legionnaire's disease beyond the lungs: a rare case of severe rhabdomyolysis and acute kidney injury from a possible vaping source. Hosp Pharm. 2025:00185787251319309.. (32 year old man presented with Legionnaire’s disease presented with marked increases in serum enzymes [ALT 449 U/L, AST 1806 U/L, Alk P not given, bilirubin 3.6 mg/dL, CPK 20,200 U/L] with acidosis and renal failure attributed to rhabdomyolysis and ultimately responding to antibiotic therapy [azithromycin and ceftriaxone], respiratory support, and hemodialysis). 39959185
Modh S, Grijalva M, Krishnan V, Chacko A, Dey S, Sanjeeva PRP, Atoot A. Legionnaires' disease on azithromycin leading to lofty liver levels. ID Cases. 2025;40:e02221.. (34 year old woman with diabetes developed Legionnaire’s disease and was treated with azithromycin [500 mg orally daily] and had a sudden rise in serum aminotransferase levels after a day of treatment with no change in bilirubin and minimal increase in Alk P, interpreted as due to the infection rather than the antibiotic). 40247848

## OTHER REFERENCE LINKS

1. Recent References on Azithromycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(azithromycin/AE)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Azithromycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=azithromycin)